# Theophylline

## OVERVIEW

### Introduction

Theophylline is an orally administered xanthine derivative that induces relaxation of smooth muscle in the bronchial tree causing bronchodilation. Theophylline is widely used in therapy of asthma and is not believed to cause liver injury.

### Background

Theophylline (thee of' i lin) is a methylxanthine related structurally to caffeine and has been widely used as a bronchodilator since the 1930s. Oral theophylline was commonly used in treatment of acute attacks of asthma and in chronic management of bronchospasm in patients with asthma and chronic obstructive pulmonary disease, but has been declining in use with the development of more effective and better tolerated inhalation therapies. Theophylline was formally approved for use in the United States in 1982 and is available in multiple generic forms for oral and intravenous use. Typical capsule or tablet sizes are 100, 200 and 300 mg. Typical dose regimens are 100 to 300 mg three to four times daily. Syrups are available for use in children. Extended release formulations are also available in sizes of 100 to 600 mg which are typically given twice daily. Dosage is highly individualized. Intravenous formations are available for management of acute asthmatic attacks. Theophylline is marketed under multiple brand names including Asmalix, Elixophyllin, Quibron-T, Respbid, Theobid, Duracaps, and Uniphyl. Common side effects of theophylline include dizziness, headache, insomnia, restlessness, tachycardia, palpitations, flushing, nausea, abdominal discomfort and diaphoresis, largely due to the effects of theophylline on the CNS, heart and muscle tissue. In high doses, theophylline can cause irritability, tremors and seizures as well as tachycardia, cardiac arrhythmias and sudden death. With the development of safer, better tolerated and more effective inhaled bronchodilators, oral theophylline has become less frequently used.

### Hepatotoxicity

Prospective studies have shown that ALT elevations occur in less than 1% of patients receiving long term oral therapy with theophylline, making it unlikely that such elevations are more common than might occur by chance. No instances of clinically apparent liver injury have been convincingly linked to theophylline use. Liver injury may occur as a part of generalized toxicity from high doses of theophylline probably as a result of hepatic complications of hypotension or anoxia from seizures or cardiac arrhythmias caused by the drug. Theophylline actually has been shown to attenuate several forms of experimental acute liver injury, and chronic caffeine (another xanthine) intake has been associated with decreased rates of chronic liver disease, cirrhosis and liver cancer.

Likelihood score: E (unlikely cause of clinically apparent liver injury in conventional oral doses).

### Mechanism of Liver Injury

Theophylline is metabolized in the liver and levels are sensitive to stimulation or inhibition of the P450 enzyme system and levels are increased by many drugs such as cimetidine, corticosteroids, macrolide and quinolone antibiotics, and interferon. Theophylline levels may be decreased by barbiturates, phenytoin and rifampicin. Similarly, theophylline may affect the metabolism of other drugs and care must be used in adding theophylline in patients on multiple medications.

### Outcome and Management

Typically, liver enzymes abnormalities that occur during therapy resolve rapidly even when theophylline is continued. Clinically apparent liver injury with jaundice does not occur or is too rare to make any statements about severity or prognosis.

Drug Class: Antiasthmatic Agents, Xanthine Derivatives

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Theophylline – Generic, Slo-Phyllin®, Thio-Dur®, Uniphyl®

DRUG CLASS

Antiasthmatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=theophylline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Theophylline | 58-55-9 | C7-H8-N4-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 18 July 2020

Zimmerman HJ. Respiratory supportive drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 717. (Expert review of hepatotoxicity published in 1999; mentions that theophylline has been incriminated in hepatic injury rarely; no mention of montelukast, zafirlukast or zileuton).
Barnes PJ. Pulmonary pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 727-49. (Textbook of pharmacology and therapeutics).
Strubelt O, Wegener F, Siegers CP. (1970). Arzneimittelforschung. (Administration of coffee or theophylline to rats sc and ip resulted in increases in serum free fatty acids levels and minimal increases in ALT and AST).
Staib AH, Schuppan D, Lissner R, Zilly W, von Bomhard G, Richter E. (1980). Pharmacokinetics and metabolism of theophylline in patients with liver diseases. Int J Clin Pharmacol Ther Toxicol. (Study of metabolism of single iv dose of theophylline in patients with various forms of liver disease showed only patients with decompensated cirrhosis had significantly lower clearance rates that might lead to higher plasma levels).
Woodcock AA, Johnson MA, Geddes DM. (1983). Theophylline prescribing, serum concentrations, and toxicity. Lancet. (Monitoring theophylline levels found high levels in 13 outpatient and 4 cases of serious adverse events and 3 deaths [seizures and cardiac arrest], but no frank clinical hepatotoxicity).
Piperno D, Pacheco Y, Bastion Y, Favre-Monet PY, Gormand F, Copere B, Kofman J, et al. (1988). Therapie. (65 year old woman and 69 year old man with asthma developed ALT elevations without jaundice 11 and 4 days after starting intravenous theophylline (peak ALT 520 and 1345 U/L), and positive rechallenge in one patient).
Drent M, Kuks PF, van den Bosch JM, Brandt KH. (1993). Ned Tijdschr Geneeskd. (Chronic overdosing with theophylline led to severe psychiatric symptoms and depression; one patient developed hypotension and ischemic hepatitis [ALT and LDH ~5000 U/L without mention of jaundice]).
Makino S, Adachi M, Ohta K, Kihara N, Nakajima S, Nishima S, Fukuda T, et al. (2006). A prospective survey on safety of sustained-release theophylline in treatment of asthma and COPD. Allergol Int. (Prospective study of 3921 patients at 66 centers receiving sustained release theophylline found no serious adverse events; only 1 patient with ALT elevation).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, one case was attributed to zafirlukast, but no other antiasthma medication mentioned).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J. (2008). Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to an antiasthma medication).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to theophylline or any other medications for asthma).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 cases [<1%] were attributed to medications for asthma, all due to montelukast and none to theophylline, zafirlukast or zileuton).
(2017). Drugs for asthma. Med Lett Drugs Ther. (Concise review of medications used for asthma including theophylline; mentions that theophylline has been replaced by safer and better tolerated agents and that side effects include nausea, vomiting, headache and insomnia and with high doses, tachycardia, cardiac arrhythmias, irritability, tremors, seizures and even sudden death; no mention of liver injury).

## OTHER REFERENCE LINKS

1 Recent References on Theophylline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Theophylline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Theophylline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Theophylline)